# Roflumilast

## OVERVIEW

### Introduction

Roflumilast is a selective inhibitor of phosphodiesterase-4 (PDE-4) that has unique antiinflammatory activity and is used to treat and prevent exacerbations of chronic obstructive pulmonary disease (COPD). Roflumilast has not been linked to significant serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Roflumilast (roe flue' mi last) is a long acting inhibitor of the enzyme, phosphodiesterase-4 (PDE-4), an oral antiinflammatory agent that is used to treat chronic obstructive pulmonary disease (COPD). PDE-4 is responsible for the metabolism of cyclic adenosine monophosphate (cAMP) and its inhibition results in increased intracellular concentrations of cAMP, an important mediator of inflammatory pathways. Roflumilast has been shown to decrease pro-inflammatory cytokines and reduce inflammatory responses in chronic pulmonary conditions including chronic bronchitis. In large controlled trials, roflumilast therapy was associated with a decrease in the numbers of severe, acute exacerbations of COPD and a modest improvement in pulmonary function test results. Roflumilast was approved is 2011 for use in patients with COPD to prevent acute exacerbations of chronic bronchitis. It is currently available in tablets of 500 µg under the brand name Daliresp and the recommended dose in 500 µg once daily. Side effects are generally mild and include diarrhea, nausea, vomiting, decreased appetite, weight loss, headache, dizziness, insomnia and back and joint pain. Rare, but potentially severe adverse reactions include depression, suicidality and hypersensitivity reactions, including angioedema.

### Hepatotoxicity

In preregistration studies, roflumilast was not associated with serum enzyme elevations or with episodes of clinically apparent liver injury. Since approval of roflumilast, there have been no published reports of hepatotoxicity, and the product label does not mention liver injury as an adverse event.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which roflumilast might cause serum aminotransferase elevations or liver injury is not known. Its lack of hepatotoxicity may relate to the very low doses used (<1 mg daily). Roflumilast is metabolized by the hepatic cytochrome P450 system (predominately CYP 3A4 and 1A2) and is susceptible to drug-drug interactions.

Drug Class: Pulmonary Disease Agents, Chronic Obstructive Pulmonary Disease Agents

Other Drugs in the Subclass: Anticholinergic Agents – Ipratropium, Tiotropium, Aclidinium; Beta-2 Adrenergic Agonists – Albuterol, Formoterol, Salmeterol, Terbutaline; Corticosteroids – Budesonide, Fluticasone; Theophylline

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Roflumilast – Daliresp®

DRUG CLASS

Pulmonary Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Roflumilast)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Roflumilast | 162401-32-3 | C17-H14-Cl2-F2-N2-O3 | Roflumilast Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 June 2018

Abbreviations used: COPD, chronic obstructive pulmonary disease; PDE-4, phosphodiesterase 4; cAMP, cyclic adenosine monophosphate.

Zimmerman HJ. Respiratory supportive drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity. The adverse effects of drugs and other chemicals upon the liver. 2nd edition. Philadelphia. Lippincott, 1999. pp 717. (Textbook of drug induced liver injury published in 1999; does not discuss roflumilast).
Barnes PJ. Pulmonary Pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1031-65. (Textbook of pharmacology and therapeutics).
Lipworth BJ. Phosphodiesterase-4 inhibitors for asthma and chronic obstructive pulmonary disease. Lancet 2005; 365 (9454): 167-75. (Review of the mechanism of action of PDE-4 inhibitors that act by increasing intracellular cAMP levels, which have antiinflammatory actions, decreasing chemotaxis, cell proliferation and production and release of cytokines; in clinical studies, roflumilast led to a reduction in the number of clinical exacerbations and “did not lead to any clinically significant changes in … laboratory test results”). 15639300
Bateman ED, Izquierdo JL, Harnest U, Hofbauer P, Magyar P, Schmid-Wirlitsch C, Leichtl S, et al. Efficacy and safety of roflumilast in the treatment of asthma. Ann Allergy Asthma Immunol 2006; 96: 679-86. (Among 693 patients with asthma treated with roflumilast [100, 250 or 500 µg daily] for 12 weeks, pulmonary function tests improved and side effects were most frequent with the highest dose, while “changes in transaminase levels were not considered clinically significant”). 16729780
Calverley PM, Sanchez-Toril F, McIvor A, Teichmann P, Bredenbroeker D, Fabbri LM. Effect of 1-year treatment with roflumilast in severe chronic obstructive pulmonary disease. Am J Respir Crit Care Med 2007; 176: 154-61. (Among 1513 patients with severe COPD treated with roflumilast [500 µg daily] or placebo for up to one year, pulmonary tests improved somewhat, but rates of acute exacerbation were similar in the two groups and adverse events of roflumilast were headache, diarrhea and nausea while “routine laboratory tests…did not show any clinically significant changes”). 17463412
Fabbri LM, Calverley PM, Izquierdo-Alonso JL, Bundschuh DS, Brose M, Martinez FJ, Rabe KF; M2-127 and M2-128 study groups. Roflumilast in moderate-to-severe chronic obstructive pulmonary disease treated with longacting bronchodilators: two randomised clinical trials. Lancet 2009; 374 (9691): 695-703. (In a pooled analysis of two placebo controlled trials in 2,131 patients with moderate-to-severe COPD, roflumilast therapy was associated with a modest improvement in pulmonary function test results but variable effects on symptoms, while side effects included decreased appetite, weight loss, nausea, diarrhea and headache and “routine laboratory tests…did not show any clinically significant changes”). 19716961
Calverley PM, Rabe KF, Goehring UM, Kristiansen S, Fabbri LM, Martinez FJ; M2-124 and M2-125 study groups. Roflumilast in symptomatic chronic obstructive pulmonary disease: two randomised clinical trials. Lancet 2009; 374 (9691): 685-94. (In a pooled analysis of two placebo controlled trials in 3091 patients with symptomatic COPD, roflumilast was associated with modest improvements in pulmonary function tests and with fewer disease relapses, while side effects included decreased appetite, weight loss, nausea, diarrhea and headache; no mention of ALT changes or liver related adverse events). 19716960
Roflumilast (Daliresp) for COPD. Med Lett Drugs Ther 2011; 53 (1369): 59-60. (Concise review of the mechanism of action, pharmacology, clinical efficacy, safety, drug interactions and costs of roflumilast shortly after its approval in the US, mentions side effects of diarrhea, nausea and weight loss, but does not mention ALT elevations or hepatotoxicity). 21778965
Drugs for asthma and COPD. Treat Guidel Med Lett 2013; 11 (132): 75-86; (Concise discussion of therapies for COPD, including smoking cessation, short and long acting bronchodilators, theophylline, corticosteroids and other therapies such as roflumilast; no mention of ALT elevations or clinically apparent liver injury with any of the agents). 23896773
Martinez FJ, Rabe KF, Sethi S, Pizzichini E, McIvor A, Anzueto A, Alagappan VK, et al. Effect of Roflumilast and Inhaled Corticosteroid/Long-Acting β2-Agonist on Chronic Obstructive Pulmonary Disease Exacerbations (RE(2)SPOND). A Randomized Clinical Trial. Am J Respir Crit Care Med 2016; 194: 559-67. (Among 2,354 patients with COPD at risk of acute exacerbations [and receiving inhaled corticosteroids and long acting beta agonists] treated with roflumilast [500 µg daily] or placebo for 52 weeks, acute exacerbations were reduced minimally [8.5%] and side effects of weight loss, diarrhea and nausea were more frequent with roflumilast; no mention of ALT elevations or liver related serious adverse events). 27585384
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to roflumilast). 25754159
Luo J, Yang L, Yang J, Yang D, Liu BC, Liu D, Liang BM, et al. Efficacy and safety of phosphodiesterase 4 inhibitors in patients with asthma: a systematic review and meta-analysis. Respirology 2018; 23: 467-77. (Systematic review of the literature on efficacy and safety of roflumilast in patients with asthma concluded that it was well tolerated “no clinically relevant alterations in …. routine laboratory tests including haematology, biochemistry and urinalysis were observed”). 29502338

## OTHER REFERENCE LINKS

1. Recent References on Roflumilast: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Roflumilast: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)